# Panobinostat

## OVERVIEW

### Introduction

Panobinostat is an oral histone deacetylase inhibitor and antineoplastic agent that is approved for use in combination with other agents in refractory or relapsed multiple myeloma. Panobinostat is associated with modest rate of minor serum enzyme elevations during therapy, but has not been linked to cases of clinically apparent liver injury.

### Background

Panobinostat (pan" oh bin' oh stat) is an oral small molecule inhibitor of histone deacetylases, thereby preventing removal of acetyl groups from histones. The accumulation of acetyl groups on histones causes cell cycle arrest and apoptotic cell death. Malignant cells are particularly sensitive to the effects of inhibition of histone deacetylases. In open label studies in patients with multiple myeloma, panobinostat in combination with bortezomib (a proteasome inhibitor) yielded overall response rates of up to 50% and some responders had long term remissions. A large, controlled trial in patients with advanced, refractory multiple myeloma demonstrated prolongation of progression-free survival by the addition of panobinostat to bortezomib and dexamethasone, but the overall survival was not different at the time of the initial analysis. Nevertheless, panobinostat was given accelerated approval for use in the United States in 2015 to be used in combination with bortezomib and dexamethasone in patients with refractory or relapsed multiple myeloma. Panobinostat is available in capsules of 10, 15 or 20 mg under the brand name Farydak. The recommended dose regimen is 20 mg three times weekly for two weeks in three week cycles until there is disease progression or unacceptable toxicity. Side effects are common and may require dose modification. The most common adverse events are thrombocytopenia, leukopenia, anemia, diarrhea, nausea, vomiting, anorexia, fatigue, fever, peripheral edema, cough and pruritus. Panobinostat therapy has also been associated with hypokalemia, hypophosphatemia, hyponatremia and mild increases in serum creatinine. Uncommon, but serious adverse events include severe diarrhea and cardiovascular events such as cardiac ischemia, arrhythmias and EKG changes including prolongation of the QTc interval.

### Hepatotoxicity

Most clinical trials of panobinostat have not reported rates of serum enzyme elevations during therapy and it is typically given in combination with other antineoplastic agents that can cause serum ALT and AST elevations. In the large controlled trial of panobinostat vs placebo in combination with bortezomib and dexamethasone, ALT elevations occurred in similar proportion of patients receiving panobinostat (31%) as placebo (38%) and values above 5 times the upper limit of normal were uncommon (1.8% and 1.3%). In addition, there have been no reports of clinically apparent liver injury with jaundice associated with panobinostat therapy. Thus, panobinostat appears to have little hepatotoxic potential and liver injury from panobinostat must be quite rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The reason why panobinostat might cause serum enzyme elevations is not known, but may be a direct toxicity to hepatocytes caused by inhibition of histone deacetylase or other enzyme activities. Panobinostat is extensively metabolized in the liver by the cytochrome P450 system (predominantly CYP 3A4 and 2D6) and drug-drug interactions are likely to occur if it is used with other agents that are inducers, inhibitors or major substrates of these microsomal enzymes.

### Outcome and Management

Serum enzyme elevations are uncommon during panobinostat therapy and are rarely dose limiting. Nevertheless, regular monitoring of liver tests with each course of therapy is recommended with more frequent monitoring if serum aminotransferase values rise. Panobinostat should be held if ALT or AST values rise above 5 times the ULN, and elevations of more than 20 times the ULN, or appearance of jaundice or symptoms of liver injury should trigger permanent discontinuation. There is no known cross sensitivity to hepatic injury among the different histone deacetylase inhibitors.

Drug Class: Antineoplastic Agents, Histone Deacetylase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Panobinostat – Farydak®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Panobinostat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Panobinostat | 404950-80-7 | C21-H23-N3-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of histone deacetylase inhibitors).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents does not discuss panobinostat).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Inhibitors of histone deacetylase. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 1230. (Textbook of pharmacology and therapeutics).
Ellis L, Pan Y, Smyth GK, George DJ, McCormack C, Williams-Truax R, Mita M, et al. (2008). Histone deacetylase inhibitor panobinostat induces clinical responses with associated alterations in gene expression profiles in cutaneous T-cell lymphoma. Clin Cancer Res. (Among 10 patients with refractory CTCL given different doses of panobinostat, 6 had a clinical response and the optimal dose was 20 mg [given Monday, Wednesday and Friday], tumor gene expression changing with treatment, often with suppression of genes governing apoptosis, angiogenesis and immune modulation).
Duvic M, Dummer R, Becker JC, Poulalhon N, Ortiz Romero P, Grazia Bernengo M, Lebbé C, et al. (2013). Panobinostat activity in both bexarotene-exposed and -naïve patients with refractory cutaneous T-cell lymphoma: results of a phase II trial. Eur J Cancer. (Among 139 patients with refractory CTCL treated with panobinostat [20 mg thrice weekly] for an average of 3 months, the overall response rate was 17% and common side effects were thrombocytopenia [47%], diarrhea [42%], fatigue [33%], nausea [32%], anorexia [21%], neutropenia [15%] and creatinine elevation [13%]; no mention of ALT elevations or hepatotoxicity).
Ghobrial IM, Campigotto F, Murphy TJ, Boswell EN, Banwait R, Azab F, Chuma S, et al. (2013). Results of a phase 2 trial of the single-agent histone deacetylase inhibitor panobinostat in patients with relapsed/refractory Waldenström macroglobulinemia. Blood. (Among 36 patients with Waldenström macroglobulin treated with panobinostat [25 or 30 mg three times weekly] for an average of 5 months, responses occurred in 17 [47%], but adverse events were frequent including diarrhea in 83%, thrombocytopenia 78%, neutropenia 69%, anemia 60%; no mention of ALT elevations or hepatotoxicity).
Cassier PA, Lefranc A, Amela EY, Chevreau C, Bui BN, Lecesne A, Ray-Coquard I, et al. (2013). A phase II trial of panobinostat in patients with advanced pretreated soft tissue sarcoma. A study from the French Sarcoma Group. Br J Cancer. (Among 47 patients with refractory, advanced soft tissue sarcoma treated with panobinostat [40 or 20 mg thrice weekly], the overall response rate was 0% and adverse events were common leading to a lowering of study dose; no mention of ALT elevations or hepatotoxicity).
San-Miguel JF, Richardson PG, Günther A, Sezer O, Siegel D, Bladé J, LeBlanc R, et al. (2013). Phase Ib study of panobinostat and bortezomib in relapsed or relapsed and refractory multiple myeloma. J Clin Oncol. (Among 47 patients with refractory multiple myeloma treated with the combination of panobinostat and bortezomib in various dose regimens, the overall response rate was 52% and toxicity was common, but manageable; no mention of ALT elevations or hepatotoxicity).
San-Miguel JF, Hungria VT, Yoon SS, Beksac M, Dimopoulos MA, Elghandour A, Jedrzejczak WW, et al. (2014). Panobinostat plus bortezomib and dexamethasone versus placebo plus bortezomib and dexamethasone in patients with relapsed or relapsed and refractory multiple myeloma: a multicentre, randomised, double-blind phase 3 trial. Lancet Oncol. (Among 768 patients with refractory multiple myeloma treated with bortezomib and dexamethasone combined with either panobinostat [20 mg thrice weekly for 2 weeks in 3 week cycles] or placebo with follow up of 6-47 months, progression-free, but not overall survival was longer with panobinostat therapy; adverse events that were more frequent with panobinostat included diarrhea, nausea, fatigue, thrombocytopenia and neutropenia; rates of serum ALT elevations were similar in the two groups [any: 31% vs 38%, and above 5 times ULN: 1.8% vs 1.3%]).
Slingerland M, Hess D, Clive S, Sharma S, Sandstrom P, Loman N, Porro MG, et al. (2014). A phase I, open-label, multicenter study to evaluate the pharmacokinetics and safety of oral panobinostat in patients with advanced solid tumors and various degrees of hepatic function. Cancer Chemother Pharmacol. (Pharmacokinetic study of panobinostat in 25 patients with advanced malignancy, found higher peak serum levels in patients with hepatic dysfunction than in those without, but similar rate of adverse events).
Berdeja JG, Hart LL, Mace JR, Arrowsmith ER, Essell JH, Owera RS, Hainsworth JD, et al. (2015). Phase I/II study of the combination of panobinostat and carfilzomib in patients with relapsed/refractory multiple myeloma. Haematologica. (Among 44 patients with advanced, refractory multiple myeloma treated with the combination of panobinostat [30 mg] and carfilzomib [20 or 45 mg/m^2^] in varying regimens, the overall response rate was 67% and adverse events were common, but manageable in most patients; ALT increases above 5 times ULN occurred in only 1 patient [2%]).
Laubach JP, Moreau P, San-Miguel JF, Richardson PG. (2015). Panobinostat for the treatment of multiple myeloma. Clin Cancer Res. (Review of the mechanism of action, pharmacology, clinical efficacy and toxicity of panobinostat as therapy of advanced multiple myeloma, mentions gastrointestinal and hematologic adverse events, but not ALT elevations or hepatotoxicity).
(2015). Panobinostat (Farydak) for multiple myeloma. Med Lett Drugs Ther. (Concise summary of the mechanism of action, clinical efficacy, safety and costs of panobinostat shortly after it was approved for use in multiple myeloma in the US, mentions that severe side effects include diarrhea, cytopenias, prolongation of the QTc interval and that “hemorrhage, infections and hepatotoxicity have also been reported”).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 363 [36%] were attributed to antibiotics, none of which were attributed to panobinostat).
Bringhen S, De Wit E, Dimopoulos MA. (2017). New agents in multiple myeloma: an examination of safety profiles. Clin Lymphoma Myeloma Leuk. (Review of the safety profiles and adverse events of newer drugs for multiple myeloma including the histone deacetylase inhibitors – romidepsin, vorinostat and panobinostat, mentions that ALT elevations above 5 times ULN occur in 8% of patients treated with romidepsin, but no mention of ALT elevations or hepatotoxicity with vorinostat or panobinostat).
Borrelli EP, McGladrigan CG. (2020). Differences in safety profiles of newly approved medications for multiple myeloma in real-world settings versus randomized controlled trials. J Oncol Pharm Pract. (Analysis of the most common adverse events reported to the FDA since approval of 4 new drugs for multiple myeloma identified the top ten adverse reactions to panobinostat to be diarrhea, death, peripheral neuropathy, fatigue, nausea, peripheral edema, anorexia, constipation, fever, vomiting and cough; no mention of ALT elevations or hepatotoxicity).
Moskowitz AJ, Horwitz SM. (2017). Targeting histone deacetylases in T-cell lymphoma. Leuk Lymphoma. (Extensive review of the mechanism of action, classification, clinical efficacy and safety of histone deacetylase inhibitors in T-cell lymphomas, mentions that panobinostat is an oral hydroxamate that is approved for use in refractory or relapsed cutaneous T cell lymphoma, more common adverse effects of which are fatigue, diarrhea, nausea, dysgeusia, thrombocytopenia, neutropenia, anorexia, weight loss and musculoskeletal pain;, no mention of ALT elevations or hepatotoxicity).
Shah RR. (2019). Safety and tolerability of histone deacetylase (HDAC) inhibitors in oncology. Drug Saf. (Review of the safety of histone deacetylase inhibitors approved for use in the US mentions that elevations in serum aminotransferase levels have been reported during therapy with romidepsin, panobinostat and belinostat but not with vorinostat, and there have been no reports of clinically apparent hepatotoxicity, except for a single case of hepatic failure arising during a clinical trial of belinostat).

## OTHER REFERENCE LINKS

1 Recent References on Panobinostat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Panobinostat/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Panobinostat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Panobinostat)